# Lecanemab

## OVERVIEW

### Introduction

Lecanemab is a human monoclonal antibody to amyloid beta which has been approved for use in Alzheimer disease. Lecanemab has not been associated with serum enzyme elevations during therapy and or linked to instances of clinically apparent liver injury.

### Background

Lecanemab (lek an’ e mab) is a human monoclonal IgG1 antibody directed against aggregated forms of amyloid beta (β), which was developed as a potential therapy for Alzheimer disease, based upon the theory that the dementia and neurological decline in Alzheimer disease are caused by accumulation of amyloid β oligomers and fibrils in the frontal lobes of the brain. Studies in animal models and in humans demonstrated that the monoclonal antibody causes a decrease in amyloid β accumulation as shown by advanced imaging techniques. In a large, randomized controlled trial, lecanemab therapy was found to decrease the rate of cognitive decline in adults with early Alzheimer disease. Therapy did not reverse or stop cognitive impairment, and the long term, clinical benefit of the amount of benefit found in the trials of lecanemab remains uncertain. Lecanemab was given approval for use in early Alzheimer disease in 2023. It is available in single dose vials of 200 mg in 2 mL and 500 mg in 5 mL (both 100 mg/mL) under the brand name Leqembi. The recommended dose is 10 mg per kilogram body weight given intravenously (over approximately 1 hour) once every 2 weeks with regularly scheduled evaluations for efficacy and safety. Common side effects include infusion reactions, headache, falls, and amyloid related imaging abnormalities (ARIA) in the brain. Uncommon, potentially severe adverse reactions include hypersensitivity reactions and severe ARIA with edema, effusions or microhemorrhage.

### Hepatotoxicity

Serum aminotransferase elevations were infrequent (less than 1%) in patients receiving lecanemab in the large controlled trials in Alzheimer disease, and they occurred in a similar rate in placebo recipients. The serum ALT and AST elevations were generally mild-to-moderate in severity, transient and asymptomatic. In the preregistration trials there were no instances of clinically apparent liver injury or severe hepatic adverse events attributed to lecanemab. Clinical use outside of randomized controlled trials has been limited so far.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

The possible mechanisms by which lecanemab might cause liver injury are unclear. Monoclonal antibodies and immunoglobulins are generally taken up and metabolized intracellularly to short peptides and amino acids. There is no evidence to suggest that inhibition of amyloid β accumulation or increase in its clearance would trigger liver injury or autoimmune liver conditions.

Drug Class: Monoclonal Antibodies, Alzheimer Disease Agents

Other Alzheimer Monoclonal Antibodies: Aducanumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lecanemab – Leqembi®

DRUG CLASS

Alzheimer Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lecanemab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lecanemab | 1260393-98-3 (https://pubchem.ncbi.nlm.nih.gov/substance/381126790) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2023

Abbreviations: ARIA-E, amyloid related imaging abnormalities with edema, effusions or microhemorrhage.

Roberson ED. Alzheimer Disease. Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 333-5. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/761269Orig1s000MedR.pdf (Multidisciplinary FDA review of lecanemab in support of its approval for use in Alzheimer disease in the US with discussion of safety mentions that the laboratory findings from the prelicensure studies did not reveal a “safety signal for hepatic related events”).
Selkoe DJ, Hardy J. (2016). The amyloid hypothesis of Alzheimer's disease at 25 years. EMBO Mol Med. (Analysis of the role of amyloid-β in the etiology of Alzheimer disease supported by findings that the dominant mutations in amyloid precursor protein [APP] or the protease that metabolizes presenilin and generates amyloid-β are associated with early onset dementia, suggesting that imbalance of generation and clearance of amyloid-β is the early and perhaps initiating factor in Alzheimer disease and that monoclonal antibody therapy by increasing clearance might help correct the dyshomeostasis).
Sevigny J, Chiao P, Bussière T, Weinreb PH, Williams L, Maier M, Dunstan R, et al. (2016). The antibody aducanumab reduces Aβ plaques in Alzheimer's disease. Nature. (Among 165 patients with early Alzheimer disease treated with 1 of 4 doses of aducanumab [1, 3, 6, or 10 mg/kg] or placebo monthly for one year, those treated with the higher doses showed evidence of decrease in brain amyloid-β accumulation and a trend for clinical improvement, but also higher rates of vasogenic edema [37% to 40%] compared with placebo [5%]; ALT elevations arose in 4 of 125 [3.2%] on aducanumab vs none of 40 on placebo).
Logovinsky V, Satlin A, Lai R, Swanson C, Kaplow J, Osswald G, Basun H, et al. (2016). Safety and tolerability of BAN2401--a clinical study in Alzheimer's disease with a protofibril selective Aβ antibody. Alzheimers Res Ther. (Among 60 patients with mild or moderate Alzheimer disease treated with one of 4 different doses of lecanemab or placebo for 12 months, treatment emergent adverse events were mild or moderate and similar to placebo with no symptomatic episodes of ARIA and the incidence of “out-of-range values in…clinical chemistry…parameters was comparable between different doses …and placebo”).
Swanson CJ, Zhang Y, Dhadda S, Wang J, Kaplow J, Lai RYK, Lannfelt L, et al. (2021). A randomized, double-blind, phase 2b proof-of-concept clinical trial in early Alzheimer's disease with lecanemab, an anti-Aβ protofibril antibody. Alzheimers Res Ther. (Among 854 adults with early Alzheimer disease treated with one of 5 dose regimens of lecanemab or placebo for 18 months, a dose of 10 mg/kg given intravenously every 2 weeks yielded the optimal results in decreasing the decline in cognitive impairment and in decreasing amyloid beta burden with only mild-to-moderate adverse events including infusion related reactions in 20% [vs 3% with placebo], ARIA-E in 10% [vs 0.8% with placebo] and with “no relative changes between lecanemab and placebo in labs”).
(2022). The Lancet. Lecanemab for Alzheimer's disease: tempering hype and hope. Lancet. (Editorial on the status of lecanemab therapy for Alzheimer disease stresses the promise of the evolving studies, but that the difference of 0.45 point [of a total of 18 points] in the progression of cognitive decline between lecanemab and placebo therapy is of unclear clinical significance and long term studies will be needed to establish the its role in management of Alzheimer disease).
van Dyck CH, Swanson CJ, Aisen P, Bateman RJ, Chen C, Gee M, Kanekiyo M, et al. (2023). Lecanemab in early Alzheimer's disease. N Engl J Med. (Among 1795 adults with early Alzheimer disease treated with lecanemab or placebo intravenously every two weeks for 18 months, there was less progression of cognitive decline and greater reduction in brain amyloid burden with lecanemab therapy, which was associated with a slightly higher total [89% vs 82%] and serious adverse events [14% vs 11%], most commonly infusion related reactions [26% vs 7%], ARIA-E [12.6% vs 1.7%], headache [11% vs 8%] and falls 10.4% vs 8.1%]; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Lecanemab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lecanemab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Lecanemab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lecanemab)